# Cycloserine

## OVERVIEW

### Introduction

Cycloserine is a broad spectrum antibiotic used as a second line agent for treatment of drug resistant tuberculosis, always in combination with other antituberculosis agents. Cycloserine is appears to have little or no hepatotoxic potential, but it is usually used in combination with agents that are known to be hepatotoxic, and its role in the reported cases of liver injury with combination therapy cannot always be excluded.

### Background

Cycloserine (sye" kloe ser' een) is an antibiotic that is currently used largely in the therapy of tuberculosis caused by multidrug resistant mycobacteria. Cycloserine is a d-alanine analogue of isoxazolidone that was isolated initially from Streptococcus orchidaceus and has moderate activity in vitro against mycobacterial species, probably acting by inhibition of mycobacterial use of amino acids and inhibition of cell wall synthesis. Importantly, there is no cross resistance between cycloserine and most other medications for tuberculosis. Cycloserine was approved for use in the United States in 1964, but its use for most indications has been replaced by more modern antituberculosis agents except in instances of multidrug resistance or of intolerance to the more potent agents such as isoniazid, rifampin and pyrazinamide. Cycloserine is available in tablets of 250 mg in generic forms and under the brand name Seromycin; the typical adult dose is 250 to 500 mg twice daily (~10-15 mg/kg/day). Common side effects are drowsiness, headache, fatigue, rash and fever; rarely, cycloserine causes more serious neurological side effects such as acute psychosis, seizures and coma. Regularly updated information on guidelines for therapy of tuberculosis is available at the Centers for Disease Control and Prevention website:

http://www.cdc.gov/tb/publications/guidelines/Treatment.htm.

### Hepatotoxicity

Cycloserine is reported to be associated with a low rate of serum aminotransferase elevations that are usually transient and asymptomatic and do not require dose modification. Cycloserine is usually used in combination with agents that are more clearly linked to liver test abnormalities, and it generally plays little or no role in these abnormalities. Cycloserine has not been definitely linked to instances of clinically apparent liver injury, but is often used with agents that are known hepatotoxins and its possible contribution cannot always be excluded.

Likelihood score: E* (unproven but suspected cause of clinically apparent liver injury).

### Mechanism of Injury

Cycloserine undergoes minimal hepatic metabolism, perhaps accounting for the absence of significant hepatotoxicity. Allergic reactions have been reported with cycloserine and, if severe, these may be accompanied by mild serum enzyme elevations.

### Outcome and Management

Cycloserine blood levels are typically monitored during therapy and the product label recommends monitoring of blood counts, renal function and routine liver tests as well.

[First line medications used in the therapy of tuberculosis in the US include ethambutol, isoniazid, pyrazinamide, rifabutin, rifampin, and rifapentine. Second line medications include streptomycin, capreomycin, cycloserine, ethionamide, fluoroquinolones such as levofloxacin and moxifloxacin, aminoglycosides such as amikacin, and para-aminosalicylic acid (PAS).]

Drug Class: Antituberculosis Agents

Other Drugs in the Class: Bedaquiline, Capreomycin, Ethambutol, Ethionamide, Isoniazid, Pyrazinamide, Rifabutin, Rifampin, Rifapentine, Streptomycin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Cycloserine – Generic, Seromycin®

DRUG CLASS

Antituberculosis Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=cycloserine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Cycloserine | 68-41-7 | C3-H6-N2-O2 | Cycloserine Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 03 November 2017

Zimmerman HJ. Antituberculosis agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 611-21. (Extensive review of hepatotoxicity of antituberculosis medications published in 1999 states that: “Several drugs employed as second-line or supplementary agents for the treatment of tuberculosis [cycloserine, capreomycin] apparently produce little or no hepatic injury”).
Verma S, Kaplowitz N. Hepatotoxicity of antituberculosis drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 483-504. (Review of hepatotoxicity of antituberculosis drugs).
Gumbo T. Chemotherapy of tuberculosis, mycobacterium avium complex disease and leprosy. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1549-70. (Textbook of pharmacology and therapeutics).
Ormerod LP, Horsfield N. Frequency and type of reactions to antituberculosis drugs: observations in routine treatment. Tuber Lung Dis 1996; 77: 37-42. (Among 1317 patients treated for active tuberculosis, hepatitis was attributed to rifampin in 1.4%, pyrazinamide in 1.2% and isoniazid in 0.3%, but none to cycloserine, ethambutol or streptomycin). 8733412
American Thoracic Society; Centers for Disease Control and Prevention (CDC); Infectious Diseases Society of America. Treatment of tuberculosis. MMWR Recomm Rep 2003; 52 (RR-11): 1-77. (Recommendations for therapy of tuberculosis including details of drug regimens, side effects, monitoring and optimal approaches to follow up; cycloserine is considered a second line agent, used largely for cases of drug resistant tuberculosis or in situations in which the first line agents are contraindicated or poorly tolerated). 12836625
Di Perri, Bonora S. Which agents should we use for the treatment of multidrug-resistant Mycobacterium tuberculosis? J Antimicrob Chemother 2004; 54: 593-602. (Multidrug resistance is defined as an organism resistant to at least isoniazid and rifampin; authors rank second-line agents as: (1) levofloxacin, aminoglycosides, and capreomycin, (2) ethionamide, ofloxacin and ciprofloxacin, (3) PAS, (4) cycloserine, (5) amoxicillin/clavulate or ampicillin/sulbactam, (6) clarithromycin, linezolid and clofazimine). 15282233
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, isoniazid was implicated in 15 cases [5% of cases overall, ranking 3rd, 13 as a single agent and 2 in combination with other agents], but no case was attributed to cycloserine). 18955056
Abubakar I, Moore J, Drobniewski F, Kruijshaar M, Brown T, Yates M, Anderson C, et al. Extensively drug-resistant tuberculosis in the UK: 1995 to 2007. Thorax 2009; 64: 512-5. (Among 678 extensively drug resistant isolates of tuberculosis reported in the UK between 2005 and 2008, 5.1% were resistant to cycloserine). 19318348
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury and 25 to antituberculosis agents, including 15 to isoniazid alone [ranking first], 6 to isoniazid combined with other agents, 3 to rifampin and pyrazinamide and 1 to dapsone, none to cycloserine). 20949552
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol 2010; 105: 2396-404. (Among 313 cases of drug induced liver injury seen between 1997 and 2008 at a large hospital in Bangalore, India, 181 [58%] were attributed to antituberculosis agents which accounted for 39 of 54 [72%] fatal cases, cycloserine was not specifically mentioned). 20648003
Arbex MA, Varella Mde C, Siqueira HR, Mello FA. Antituberculosis drugs: drug interactions, adverse effects, and use in special situations. Part 2: second line drugs. J Bras Pneumol 2010; 36: 641-56. (Analysis of adverse effects of second line drugs for tuberculosis; cycloserine has neurological adverse effects which can be severe, but no mention is made of hepatotoxicity). 21085831
Caminero JA, Sotgiu G, Zumla A, Migliori GB. Best drug treatment for multidrug-resistant and extensively drug-resistant tuberculosis. Lancet Infect Dis 2010; 10: 621-9. (Review of drug-resistance in tuberculosis mentions that cycloserine is a cornerstone of treatment for multidrug resistant strains, major drawbacks being its neurological side effects and its short shelf-life; no mention of hepatotoxicity). 20797644
Palmero D, Castagnino J, Musella RM, Mosca C, González Montaner P, de Casado GC. Difficult clinical management of anti-tuberculosis DRESS syndrome. Int J Tuberc Lung Dis 2013; 17: 76-8. (Analysis of 11 patients with DRESS syndrome attributed to antituberculosis medications including isoniazid, rifampin, ethambutol, pyrazinamide and others usually in combination, but none were receiving cycloserine). 23114284
Kaswala DH. Drug rash with eosinophilia and systemic symptoms syndrome due to anti-TB medication. J Family Med Prim Care 2013; 2: 83-5. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/24479051) (68 year old man with pulmonary tuberculosis developed skin rash, eosinophlia and liver test abnormalities 8 weeks after starting isoniazid, pyrazinamide, rifampin and ethambutol, which resolved within 4 weeks of stopping and with corticosteroid therapy, and did not recur when treated with cycloserine and moxifloxacin).
Bhushan B, Chander R, Kajal NC, Ranga V, Gupta A, Bharti H. Profile of adverse drug reactions in drug resistant tuberculosis from Punjab. Indian J Tuberc 2014; 61: 318-24. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/25675695) (Among 207 patients with drug resistant tuberculosis with an adverse drug reaction while on second line regimen, there were 24 instances of hepatitis which were severe and required discontinuation in 5, 3 of which were attributed to pyrazinamide, recurring with restarting; no mention of cycloserine).
Tandon VR, Rani N, Roshi, Gupta R, Arora M, Khajuria V, Mahajan V. Cycloserine induced psychosis with hepatic dysfunction. Indian J Pharmacol 2015; 47: 230-1. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/25878391) (45 year old man with multidrug resistant pulmonary tuberculosis developed acute psychosis 18 months after starting a second line regimen that included cycloserine, the abnormal behavior resolving with stopping and reappearing with restarting cycloserine at which time abnormal liver test results were identified [bilirubin 5.4 mg/dL, ALT 202 U/L, Alk P not given], subsequent course not described).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 53 cases [6%] were attributed to antituberculosis medications, but none to cycloserine). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Cycloserine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Cycloserine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Cycloserine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Cycloserine)